# Flurbiprofen

## OVERVIEW

### Introduction

Flurbiprofen is a nonsteroidal antiinflammatory drug (NSAID) used in treatment of mild-to-moderate pain and symptoms of chronic arthritis. Flurbiprofen has been linked to a low rate of serum enzyme elevations during therapy and to rare instances of clinically apparent acute liver injury.

### Background

Flurbiprofen (flur" bi proe' fen) belongs to the propionic acid derivative class of NSAIDs, similar to fenoprofen, ketoprofen, naproxen, and ibuprofen. Like other NSAIDs, flurbiprofen is a cyclo-oxygenase (Cox-1 and -2) inhibitor that blocks the formation of proinflammatory prostaglandins that are important in pain and inflammatory pathways. Flurbiprofen has analgesic as well as antipyretic and antiinflammatory activities. Flurbiprofen was approved in the United States in 1988. Current indications in the United States are limited to chronic joint pain due to osteoarthritis and rheumatoid arthritis. The recommended dose in adults with chronic arthritis is 50 to 100 mg two to four times daily, with a maximum dose of 300 mg daily. Flurbiprofen is available by prescription in the form of capsules or tablets of 50 and 100 mg in both generic and trade formulations (Ansaid). Because of the need for 2 to 4 times daily dosing, flurbiprofen has not been widely used and fewer than 500,000 prescriptions are written for its use in the United States yearly. As with other NSAIDs, flurbiprofen is generally well tolerated, but side effects can include headache, dizziness, somnolence, gastrointestinal upset, nausea, abdominal discomfort, diarrhea, edema and hypersensitivity reactions. As with other NSAIDS, flurbiprofen has several potential serious adverse effects, including severe gastrointestinal complications [such as ulcers, bleeding, or perforation], increase risk of cardiovascular thrombotic events [such as myocardial infarction or stoke], renal dysfunction, heart failure and edema, exacerbation of asthma, infertility, fetal toxicity and hypersensitivity reactions.

### Hepatotoxicity

Prospective studies show that mild elevations in serum aminotransferase levels can occur in up to 15% of patients taking NSAIDs such as flurbiprofen, but the abnormalities are generally transient, mild and asymptomatic, often resolving even with drug continuation. Marked aminotransferase elevations above 3 times the upper limit of normal (ULN) occur in less than 1% of patients. Clinically apparent liver injury with jaundice from flurbiprofen is rare and only individual case descriptions have been published. The latency to onset is within 1 to 4 weeks of starting. The pattern of enzyme elevations is typically cholestatic, but hepatocellular cases have been described. Immunoallergic features are present in some cases (low grade fever, rash), but are generally not prominent, and autoantibody formation is rare. Most cases resolve promptly on stopping therapy. Flurbiprofen is not mentioned in large case series on drug induced liver injury or acute liver failure from the United States, but was listed as the second most common agent implicated in drug-induced liver injury in a case series from Turkey, one of which was fatal.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of flurbiprofen hepatotoxicity is not known, but likely to be due to an idiosyncratic hypersensitivity reaction to an intermediate of its metabolism. Flurbiprofen is extensively metabolized by the liver, largely through the cytochrome P450 pathway (CYP 2C9).

### Outcome and Management

Severity ranges from asymptomatic elevations in serum aminotransferase levels, to symptomatic hepatitis with or without jaundice, to acute liver failure and death. There are no convincing cases of chronic hepatitis or vanishing bile duct syndrome attributable to flurbiprofen use in the published literature. Patients with clinically apparent flurbiprofen induced liver injury should avoid other propionic acid derivatives such as fenoprofen, ibuprofen, ketoprofen, and naproxen.

Drug Class: Nonsteroidal Antiinflammatory Drugs

## CASE REPORT

### Case 1. Cholestatic hepatitis due to flurbiprofen.(1)

A 28 year old man developed pruritus and jaundice 3 to 4 weeks after starting flurbiprofen (100 mg twice daily) for posttraumatic muscle and joint pains. He denied rash, fever and abdominal pain. He had no previous history of liver disease, alcohol abuse or risk factors for viral hepatitis. He took no other medications or herbal supplements and had no history of drug allergies. On presentation, he was jaundiced, but had no hepatic tenderness, organomegaly or signs of chronic liver disease. Laboratory testing showed a total bilirubin of 18.4 mg/dL (direct 10.0 mg/dL), ALT 75 U/L, AST 68 U/L, GGT 480 U/L and alkaline phosphatase 574 U/L (Table). A complete blood count, INR and albumin levels were normal. Tests for hepatitis A, B, C and E were negative as were autoantibodies. Abdominal ultrasound was normal and without evidence of biliary obstruction, which was verified by magnetic resonance cholangiopancreatography (MRCP). Flurbiprofen was stopped, but his liver tests worsened over the following week. A liver biopsy showed intrahepatic cholestasis without fibrosis, steatosis or features of extrahepatic obstruction. He was treated with prednisolone, ursodiol and cholestyramine and began to improve. These agents were tapered and eventually stopped, but his liver tests remained abnormal until 6 months after stopping flurbiprofen.

#### Key Points

Medication: | Flurbiprofen (200 mg daily for ~1 month)
Pattern: | Cholestatic (R=0.5)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 to 4 weeks
Recovery: | Complete recovery 6 months after stopping
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Flurbiprofen (200 mg daily) started for joint pain
4 weeks | 0 | 75 | 574 | 18.4 | Flurbiprofen stopped
5 weeks | 1 week | 74 | 587 | 26.4 | Liver biopsy
4 months | 3 months | 54 | 246 | 10.0 | Prednisolone stopped
7 months | 6 months | 35 | 124 | 1.3 | Ursodiol stopped
Normal Values | | <35 | <128 | <1.2

#### Comment

This was a convincing case of cholestatic hepatitis arising a month after starting flurbiprofen. No other medications were being taken, and clinical evaluation including MRCP identified no other cause of acute cholestatic jaundice. The course was moderately severe and protracted, but recovery was eventually complete. Clinically apparent liver injury from NSAIDs varies greatly in clinical features and outcomes. Some agents are associated with hepatocellular injury that can be severe (diclofenac, etodolac) and others with cholestatic hepatitis (meloxicam, celecoxib), and some agents with a long latency and autoimmune features (diclofenac, etodolac) and others with a short latency and immunoallergic features (oxaprozin, celecoxib). The NSAIDs are some of the most frequently taken medications worldwide, and hepatotoxicity from their use is clearly quite rare and generally only mild-to-moderate in severity and self-limited in course.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Flurbiprofen – Generic, Ansaid®

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Flurbiprofen)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Flurbiprofen | 5104-49-4 | C15-H13-F-O2

## CITED REFERENCES

1 Dogan S, Celikbilek M, Demirkan K, Yilmaz S, Deniz K, Gursoy S, Yucesoy M. Prolonged Cholestatic Jaundice Associated With Flurbiprofen. J Pharm Pract 2013; 27: 396-398. 24381241

## ANNOTATED BIBLIOGRAPHY

References updated: 08 August 2025

Abbreviations: NSAIDs, nonsteroidal antiinflammatory drugs.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-53. (Expert review of hepatotoxicity published in 1999; flurbiprofen is listed as having a very low incidence of hepatotoxicity which is typically hepatocellular).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists: pathology and clinical presentation of hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd. Amsterdam: Elsevier, 2013, pp. 369-401. (Review of hepatotoxicity of NSAIDs mentions that only a single case of hepatotoxicity from flurbiprofen has been reported [Kotowski 1982]).
Grossner T, Smyth EM, Fitzgerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. pp. 685-709. (Textbook of pharmacology and therapeutics).
Kotowski KE, Grayson MF. Side effects of non-steroidal anti-inflammatory drugs. Br Med J (Clin Res Ed) 1982; 285 (6338): 377. (56 year old woman with mixed connective tissue disease developed abdominal pain, fever, rash and jaundice 3 months after restarting flurbiprofen [bilirubin 1.3 mg/dL, AST >1200 U/L, Alk P 150 U/L], resolving within 7 weeks of stopping; authors mention two other cases reported by the manufacturer, one with jaundice and recurrence on rechallenge). 6807485
Zimmerman HJ. Update of hepatotoxicity due to classes of drugs in common clinical use: non-steroid drugs, anti-inflammatory drugs, antibiotics, antihypertensives, and cardiac and psychotropic agents. Semin Liver Dis 1990; 10: 322-8. (Extensive review of NSAID related liver injury states that flurbiprofen has only rarely been linked to liver injury). 2281340
Ruiz-Rebollo ML, Delgado-Fontaneda E, Testillano-Tarrero M, Moretó-Canela M. [Cholestasis caused by hypersensitivity to flurbiprofen]. Rev Esp Enferm Dig 1992; 82: 130-1. Spanish. PMID: 1389551 (63 year old woman developed fatigue, fever and rash within a day of starting flurbiprofen and subsequently developed jaundice 20 days later [bilirubin 14.6 mg/dL, ALT 86 U/L, Alk P 478 U/L], resolving rapidly upon stopping).
Walker AM. Quantitative studies of the risk of serious hepatic injury in persons using nonsteroidal antiinflammatory drugs. Arthritis Rheum 1997; 40: 201-8. (Review of population based studies of NSAID use and hepatic injury; frequency of clinically apparent liver injury from NSAIDs overall was ~10 cases per 100,000 patient-years of use; flurbiprofen is not specifically discussed). 9041931
Lacroix I, Lapeyre-Mestre M, Bagheri H, Pathak A, Montastruc JL; Club de Reflexion des cabinets de Groupe de Gastro-Enterologie (CREGG); General Practitioner Networks. Nonsteroidal anti-inflammatory drug-induced liver injury: a case-control study in primary care. Fundam Clin Pharmacol 2004; 18: 201-6. (Case controlled study of patients presenting with suspected drug induced liver injury in a general practice context in Southern France found 88 cases which were matched with 178 controls; 22 cases vs 16 controls had been exposed to NSAIDs; 5 diclofenac, 4 ibuprofen, 4 ketoprofen, 2 niflumic acid, 1 flurbiprofen, and 1 meloxicam, rest to salicylates which were as frequently used in controls as cases; there were no fatalities and cases were more common in women than men). 15066135
Rubenstein JH, Laine L. Systematic review: the hepatotoxicity of non-steroidal anti-inflammatory drugs. Aliment Pharmacol Ther 2004; 20: 373-80. (NSAIDs are the most commonly used drugs in the US and account for a large proportion of cases of hepatic injury, but the frequency is quite rare. Among 7 population based studies, hospitalization occurred in 22.4/100,000 patient-years of NSAID use [rate ratio=1.5] and deaths from liver injury occurred in ~1/100,000 patient-years; frequency of injury did not increase with age and was no more common in women than men; in case controlled studies, higher odds ratio for liver injury was found with sulindac, indomethacin, piroxicam, and diclofenac; no mention of flurbiprofen). 15298630
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-1101. (Survey of all cases of fatal drug induced liver injury from Swedish Adverse Drug Reporting system from 1966-2002; among 103 cases, none were attributed to flurbiprofen). 16165719
Lapeyre-Mestre M, de Castro AM, Bareille MP, Garcia del Pozo J, Requejo AA, Arias LM, Montastruc J-L, et al. Non-steroidal anti-inflammatory drug-related hepatic damage in France and Spain: analysis from national spontaneous reporting systems. Fundam Clin Pharmacol 2006; 20: 391-5. (Analysis of reports of liver injury from NSAIDs from France and Spain from 1982-2001; flurbiprofen is not specifically mentioned). 16867024
Arellano FM, Yood MU, Wentworth CE, Oliveria SA, Rivero E, Verman A, Rothman K. Use of cyclo-oxygenase 2 inhibitors (COX-2) and prescription non-steroidal anti-inflammatory drugs (NSAIDS) in UK and USA populations Implications for COX-2 cardiovascular profile. Pharmacoepidemiol Drug Saf 2006; 15: 861-72. (Surveys from the UK and USA indicate that ibuprofen, naproxen and diclofenac were the most commonly used NSAIDs; flurbiprofen was not among the top 10 agents used). 17086563
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam and 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen]; none were attributed to flurbiprofen). 18955056
Bessone F. Non-steroidal anti-inflammatory drugs: What is the actual risk of liver damage? World J Gastroenterol 2010; 16: 5651-61. (Review of estimated frequency of drug induced liver injury due to NSAIDs from large published epidemiological studies; no discussion of flurbiprofen). 21128314
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 7 to NSAIDs, including 4 to bromfenac, 2 diclofenac and 1 etodolac, but none to other NSAIDS including flurbiprofen, ibuprofen and naproxen). 20949552
Dogan S, Celikbilek M, Demirkan K, Yilmaz S, Deniz K, Gursoy S, Yucesoy M. Prolonged Cholestatic Jaundice Associated With Flurbiprofen. J Pharm Pract 2013; 27: 396-8. (28 year old man developed pruritus and jaundice 1 month after starting flurbiprofen [bilirubin 18.4 mg/dL, ALT 75 U/L, Alk P 574 U/L], resolving slowly over the 6 months after stopping: Case 1). 24381241
Gulmez SE, Larrey D, Pageaux GP, Lignot S, Lassalle R, Jové J, Gatta A, et al. Transplantation for acute liver failure in patients exposed to NSAIDs or paracetamol (acetaminophen): the multinational case-population SALT study. Drug Saf 2013; 36: 135-44. (Among 600 patients undergoing liver transplantation for acute liver failure at 52 European liver transplant centers between 2005 and 2007, 301 were considered idiopathic and had received a medication within 30 days of onset, including acetaminophen in 192 and NSAIDs in 40, but no specific mention of flurbiprofen). 23325533
Lapeyre-Mestre M, Grolleau S, Montastruc JL; Association Française des Centres Régionaux de Pharmacovigilance (CRPV). Adverse drug reactions associated with the use of NSAIDs: a case/noncase analysis of spontaneous reports from the French pharmacovigilance database 2002-2006. Fundam Clin Pharmacol 2013; 27: 223-30. (Analysis of serious adverse events reporting to a French pharmacovigilance database found highest cumulative rates for liver related reports for nimesulide [0.15 per million defined daily doses], followed by diclofenac [0.09], ketoprofen [0.09], piroxicam [0.06], naproxen [0.04], and meloxicam [0.03] being significant in case/non-case analyses for nimesulide, diclofenac and piroxicam only; no mention of flurbiprofen). 21929527
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 6 attributed to diclofenac (ranking 2nd), but none were due to flurbiprofen). 23419359
Dağ MS, Aydınlı M, Oztürk ZA, Türkbeyler IH, Koruk I, Savaş MC, Koruk M, et al. Drug- and herb-induced liver injury: a case series from a single center. Turk J Gastroenterol 2014; 25: 41-5. (Among 82 cases of drug or herbal product induced liver injury seen at a single referral center in Turkey between 2008 and 2012, NSAIDs were the most common class of agents implicated, accounting for 19 cases [23%] of which 7 were due to flurbiprofen, one of which resulted in acute liver failure). 24918129
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and Outcomes of 899 Patients With Drug-Induced Liver Injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 28 cases were attributed to an NSAID including 15 to diclofenac, 3 celecoxib, 3 meloxicam, 2 oxaprozin, 2 etodolac, and 1 each for ibuprofen, sulindac, and valdecoxib, but none for flurbiprofen or fenoprofen). 25754159
Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9. (Among 1231 cases of suspected drug induced liver injury enrolled in a prospective study in the US between 2004 and 2014, 30 [2%] were considered due to an NSAID, including diclofenac [n=16], celecoxib [3], meloxicam [3], etodolac [2], oxaprozin [2], ibuprofen [2], and sulindac [1], while none were attributed to flurbiprofen). 26601797
Nonopioid drugs for pain. Med Lett Drugs Ther. 2022;64(1645):33-40. PMID:. (Concise review of the nonopioid drugs for pain mentions that NSAIDs are considered to be more effective than acetaminophen for mild to moderate pain and that they can cause small increases in serum aminotransferase levels but that serious hepatotoxicity is rare, occurring most frequently with diclofenac, while cholestatic hepatitis has been reported with use of celecoxib). 35231019
Bonkovsky HL, Ghabril M, Nicoletti P, Dellinger A, Fontana RJ, Barnhart H, Gu J, et al; US DILIN Investigators. Drug-induced liver injury (DILI) ascribed to non-steroidal anti-inflammatory drugs (NSAIDs) in the USA-update with genetic correlations. Liver Int. 2024;44:1409-1421.. (Among 55 cases of drug induced liver injury attributed to NSAIDs enrolled in a U.S. database between 2004 and 2022, 29 were attributed to diclofenac, 7 to celecoxib, 5 to ibuprofen, 4 to etodolac and meloxicam, 2 to oxaprozin, and 1 to naproxen and sulindac, but none to flurbiprofen). 38451034
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be attributed to prescribed medications, at rates for NSAIDs of 1:7,700 for sulindac, 1:8,300 for indomethacin, 1:9,100 for naproxen, 1:11,000 for ibuprofen, 1:12,500 for diclofenac, and 1:14,300 for celecoxib; flurbiprofen was not mentioned). 38913369
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver injury caused by prescription drugs. Drug Saf. 2025;48:151-160.. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 23 cases due to diclofenac for an estimated incidence of 1 per 4,800 new persons treated each year, while other NSAIDs had lower numbers and estimated rates, including celecoxib [4, 1:25,000] and meloxicam [n=3, 1:87,000], there were no cases due to flurbiprofen and incidence could not be estimated). 39317916
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 458 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, 49 were attributed to NSAIDs, including 19 [4.1%] to diclofenac, 14 [3.0%] to nimesulide and 11 [2.4%] to ibuprofen, and 1 case each to celecoxib, ketoprofen, ketorolac, meloxicam, and piroxicam, but none to flurbiprofen [personal communication]). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Flurbiprofen: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Flurbiprofen/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Flurbiprofen: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Flurbiprofen)